# Casimersen

## OVERVIEW

### Introduction

Casimersen is a synthetic antisense oligonucleotide designed to cause skipping of abnormal exons in the synthesis of the dystrophin gene and that is used to treat Duchenne muscular dystrophy. Casimersen has not been reported to cause ALT elevations during therapy and has not been linked to instances of acute liver injury with symptoms or jaundice.

### Background

Casimersen (kas” i mer’ sen) is a synthetic antisense oligonucleotide designed to cause exon 45 skipping during the processing of the mRNA of the dystrophin gene, which encodes an essential protein for muscle integrity and is mutated in muscular dystrophy. Patients with Duchenne muscular dystrophy typically have deletion mutations in exons [43 to 55], which disrupt the open-reading frame and the normal synthesis of dystrophin. The lack of functional dystrophin leads to damage to muscles during contraction that eventually results in replacement of normal muscle by fibrous tissue and fat. Duchenne muscle dystrophy is an X-linked disorder that presents clinically in boys by the age of 2 or 3 years and often results in loss of ambulation by age 10, ventilation dependency by age 20, and premature death within 5 to 20 years thereafter. In animal models of muscular dystrophy, casimersen resulted in skipping of exon 45 and creation of a truncated but functional dystrophin gene. In a placebo controlled trial of casimersen in patients with Duchenne muscular dystrophy with mutations in exon 45 amenable to correction by the drug, dystrophin protein levels increased in treated subjects and not in controls. The studies are ongoing to assess whether therapy is associated with clinical improvement or in stabilization of disease as measured by tests of motor function such as 6 minute walk tests or time to rise from a supine position. Longer term studies are underway to determine whether ambulation and ventilation can be maintained with continued treatment compared to historical studies of the natural history of Duchenne muscular dystrophy. Based upon changes in dystrophin levels, casimersen was given accelerated approval for use in the United States in 2021. Indications are limited to patients with Duchenne muscular dystrophy with a confirmed mutation that was correctable by exon 45 skipping. Casimersen is available in solution in single dose vials of 100 mg in 2 mL (50 mg/mL). The recommended regimen is 30 mg per kg body weight once weekly by intravenous infusion. Side effects of casimersen are generally mild but can include injection site reactions, cough, fever, headache, symptoms of upper respiratory infection, diarrhea, ear and throat pain, dizziness, and rash. Renal toxicity, which was observed in preclinical studies in animals, was not found in human trials but monitoring for renal function is recommended. The weekly intravenous infusions of casimersen is facilitated by insertion of an indwelling venous access catheter, which may predispose to serious complications such as infection, thrombosis, and septicemia with long term use.

### Hepatotoxicity

Duchenne muscular dystrophy is rare, affecting ~1:5000 newborn boys, and those with deletion mutants in exon 45 that would be amenable to casimersen therapy account for only 5% to 8% of patients with the disease. The pivotal trials of casimersen were conducted in rather small numbers of patients, and the full spectrum of its toxicity is probably not fully known. Nevertheless, serum aminotransferase elevations were not identified in the registration trials of casimersen, and there were no drug discontinuations or dose adjustments for hepatic adverse events and no episodes of clinically apparent liver injury. Thus, casimersen has not been linked to instances of acute hepatitis or jaundice, but it has had limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why casimersen or other RNA antisense therapeutics used in children with Duchenne muscular dystrophy might cause hepatic injury is unknown. One possibility is that exon skipping may cause disruption of translation of other genes in hepatocytes. Casimersen and other antisense molecules are largely excreted unchanged in the urine and have little effect on cytochrome P450 enzyme activities or metabolism of other drugs.

### Outcome and Management

Casimersen therapy has not been associated with liver injury, either in the form of minor serum enzyme elevations or clinically apparent liver injury. There is no reason to suspect cross reactivity of the hepatic injury with other antisense therapies or drugs used to treat Duchenne muscular dystrophy. Regular monitoring of liver tests during therapy is not generally recommended.

Drug Class: Genetic Disorder Agents

Other Therapeutic Antisense RNA Agents for Duchenne Muscular Dystrophy: Eteplirsen, Golodirsen, Viltolarsen

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Casimersen – Amondys 45®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Casimersen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Casimersen | 1422958-19-7 | C22-H40-N7O9-P

## ANNOTATED BIBLIOGRAPHY

References updated: 29 November 2022

Abbreviations: siRNA, small interfering RNA; RNAi, RNA interference.

Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to siRNA or antisense therapies or other medications for muscular dystrophy).
Chi X, Gatti P, Papoian T. (2017). Safety of antisense oligonucleotide and siRNA-based therapeutics. Drug Discov Today. (Oligonucleotide and siRNA based treatments are currently being evaluated in several diseases and have been found to have unexpected toxicities including antisense thrombocytopenia [mipomersen, drisapersen] and peripheral neuropathy [revusiran]; no discussion of hepatotoxicity).
Levin AA. (2019). Treating disease at the RNA level with oligonucleotides. N Engl J Med. (Review of the mechanism of action, current status and future promise of RNA based therapies that use synthetic oligonucleotides to modulate RNA function and have been applied to diseases ranging from hemophilia, amyloidosis, muscular dystrophy and hyperlipidemia).
Messina S, Vita GL. (2018). Clinical management of Duchenne muscular dystrophy: the state of the art. Neurol Sci. (Review of current optimal clinical management of Duchenne muscular dystrophy focusing upon standard respiratory, cardiovascular, orthopedic and nutritional support as well as recent innovative approaches to therapy including exon skipping and premature stop codon suppression).
Setten RL, Rossi JJ, Han SP. (2019). The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]).
Verhaart IEC, Aartsma-Rus A. (2019). Therapeutic developments for Duchenne muscular dystrophy. Nat Rev Neurol. (Review of mechanisms of action, challenges, and clinical efficacy of new molecular approaches to therapy of muscular dystrophy including gene therapy with viral vectors, exon skipping using antisense oligonucleotides [casimersen, eteplirsen, drisapersen, golodirsen, viltolarsen], stop coding readthrough [ataluren], gene addition, CRISPR-Cas9 genome editing, and myoblast transplantation).
FDA Multi-Disciplinary Review and Evaluation. Casimersen. 2021. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/213026Orig1s000MedR.pdf (The FDA clinical review of casimersen for efficacy and safety found increases in dystrophin levels in muscle biopsies after 48 weeks of treatment; therapy required intravenous infusions once weekly and sometimes necessitated insertion of a venous access port which can have major complications, but there were no serious adverse events attributable to the medication itself and no hepatic related serious adverse events or discontinuations because of liver toxicity; no mention of changes in ALT levels during therapy except that there were no changes in laboratory values indicative of toxicity).
Shirley M. (2021). Casimersen: first approval. Drugs. (Review of the mechanism of action, chemical structure, history of development, clinical efficacy and safety of casimersen makes no mention of ALT elevations during therapy or hepatotoxicity).
(2021). Casimersen (Amondys 45) for Duchenne muscular dystrophy. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy and safety of casimersen shortly after its approval for use in the US mentions that it is the fifth agent approved for therapy of Duchenne muscular dystrophy and the first to target exon 45 of the dystrophic gene; does not mention ALT elevations or hepatotoxicity).
Wagner KR, Kuntz NL, Koenig E, East L, Upadhyay S, Han B, Shieh PB. (2021). Safety, tolerability, and pharmacokinetics of casimersen in patients with Duchenne muscular dystrophy amenable to exon 45 skipping: a randomized, double-blind, placebo-controlled, dose-titration trial. Muscle Nerve. (Preliminary report of pharmacokinetic and safety studies of casimersen in 12 boys ages 7 to 21 years with Duchenne muscular dystrophy who were treated for 12 weeks with either casimersen [in gradually increasing doses] or placebo during which adverse events were mostly mild and considered unrelated to the active drug; with extended open label therapy for another 132 weeks in all 12 children, casimersen was well tolerated with no drug discontinuations or dose adjustments and no hepatic adverse events, although one child developed sepsis, septic emboli and vena cava thrombosis due to a venous port being used to administer the antisense molecule).
Alhamadani F, Zhang K, Parikh R, Wu H, Rasmussen TP, Bahal R, Zhong XB, Manautou JE. (2022). Adverse drug reactions and toxicity of the Food and Drug Administration-approved antisense oligonucleotide drugs. Drug Metab Dispos. (Review of the adverse side effects of oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, nusinersen, inotersen, eteplirsen, golodirsen, viltolarsen and casimersen; hepatotoxicity has been described with use of mipomersen [now withdrawn] and inotersen but not with the agents used for Duchenne muscular dystrophy).
Zakeri SE, Pradeep SP, Kasina V, Laddha AP, Manautou JE, Bahal R. (2022). Casimersen for the treatment of Duchenne muscular dystrophy. Trends Pharmacol Sci. (Brief and pictorial description of the structure, mechanism of action and clinical effects of casimersen as therapy for Duchenne muscular dystrophy; no mention of hepatotoxicity or ALT elevations during therapy).

## OTHER REFERENCE LINKS

1 Recent References on Casimersen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Casimersen/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Casimersen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Casimersen)